# Ribociclib

## OVERVIEW

### Introduction

Ribociclib is a unique cyclin-dependent kinase inhibitor that is used in combination with aromatase inhibitors in the treatment of postmenopausal women with metastatic breast cancer. Ribociclib is associated with a moderate rate of serum aminotransferase elevations during therapy, and to clinically apparent liver injury in a proportion of these.

### Background

Ribociclib (rye" boe sye' klib) is an orally available, small molecule inhibitor of cyclin-dependent kinases 4 and 6 that is used in combination with aromatase inhibitors in the therapy of postmenopausal women with metastatic breast cancer that is positive for the estrogen hormone receptor (ER+), but negative for human epidermal growth factor receptor 2 (HER2-). The cyclin kinases 4 and 6 regulate the cellular transition from the G1 to the S phase of the cell cycle acting through the retinoblastoma protein (Rb) pathway. Inhibition of this transition blocks the progression of the cell cycle and results in growth arrest in rapidly dividing cells. Components of this pathway are often mutated or overexpressed in cancer cells. In several clinical trials, the addition of ribociclib to letrozole (aromatase inhibitor) therapy of advanced or metastatic breast cancer (ER+, HER2-) in postmenopausal women was associated with a prolongation of disease-free but not overall survival. Ribociclib received accelerated approval for use in the United States in 2017. Ribociclib is under investigation as therapy of several solid tumors and lymphomas, but the initial indications were limited to advanced or metastatic ER+, HER2- breast cancer in postmenopausal women given in combination with an aromatase inhibitor. Ribociclib is available in tablets of 200 mg under the brand name Kisqali, and the initial recommended dose is 600 mg once daily in 21 day cycles every 28 days indefinitely or until there is disease progression. Common side effects include neutropenia, fatigue, nausea, diarrhea, anorexia, thrombocytopenia, headache and back pain. Less common, but potentially severe adverse reactions include prolongation of the QTc interval, severe neutropenia, fever and infections, and embryo-fetal toxicity.

### Hepatotoxicity

In the large clinical trials, adverse events were common and led to dose reductions in 45% of patients and discontinuation in 7%. In preregistration clinical trials, ALT elevations occurred in 46% of ribociclib vs 36% of control subjects and elevations above 5 times the ULN in 10% vs 1%. In one study, 1% of recipients developed clinically apparent liver injury with jaundice, but all recovered. The liver injury arose after 3 to 5 cycles and presented with asymptomatic elevations in serum ALT followed by symptoms and jaundice. Immunoallergic and autoimmune features were not present, although liver histology sometimes showed autoimmune hepatitis-like features. Recovery was slow (3 to 5 months), but ultimately complete. Restarting ribociclib resulted in more rapid and severe recurrence. Thus, experience with ribociclib is limited, but it appears to be capable of causing significant liver injury.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations and liver injury from ribociclib therapy are not known. Ribociclib is extensively metabolized in the liver largely through the CYP 3A4 pathway and liver injury might be caused by production of a toxic or immunogenic intermediate. On the other hand, inhibition of cyclin-dependent kinases 4 and 6 may also affect hepatocytes and have direct toxicity. Because it is a substrate for CYP 3A4, ribociclib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

The product label for ribociclib recommends prospective monitoring of liver tests during therapy, with values obtained before starting, at 2 week intervals during the first two cycles and at the beginning of the ensuing 4 cycles, and “as clinically indicated” thereafter. The product label also provides careful recommendations for dose interruption, reduction or discontinuation based upon toxicities (neutropenia, liver injury, QTc prolongation), with dose interruption until recovery for aminotransferase elevations above 3 times ULN, interruption until normal and subsequent dose reduction if above 5 times ULN, and permanent discontinuation if above 20 times ULN or in the presence of ALT elevations and jaundice. There is no information regarding cross reactivity in risk for adverse events, hypersensitivity or hepatic injury between ribociclib and palbociclib or other cyclin-dependent kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Cyclin-Dependent Kinase Inhibitor Drugs: Palbociclib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ribociclib – Kisqali®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ribociclib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ribociclib | 1211441-98-3 | C24-H29-N7-O2 | Ribociclib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 08 May 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors including palbociclib and ribociclib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not palbociclib or ribociclib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Turner NC, Ro J, André F, Loi S, Verma S, Iwata H, Harbeck N, et al.; PALOMA3 Study Group. Palbociclib in hormone-receptor-positive advanced breast cancer. N Engl J Med 2015; 373: 209-19. (Among 521 women with advanced breast cancer [ER+, HER2-] treated with letrozole and either palbociclib or placebo for up to 1 year, progression-free survival was prolonged by adding palbociclib [9.2 vs 3.8 months], and side effects were more common including neutropenia [62% vs 1%] and fatigue [38% vs 26%]; no mention of ALT elevations or hepatotoxicity). 26030518
Mangini NS, Wesolowski R, Ramaswamy B, Lustberg MB, Berger MJ. Palbociclib: A novel cyclin-dependent kinase inhibitor for hormone receptor-positive advanced breast cancer. Ann Pharmacother 2015; 49: 1252-60. (Review of the structure, mechanism of action, pharmacology, clinical efficacy and safety of palbociclib as therapy of metastatic breast cancer, discusses neutropenia and infections, but does not mention ALT elevations or hepatotoxicity). 26324355
Hortobagyi GN, Stemmer SM, Burris HA, Yap YS, Sonke GS, Paluch-Shimon S, Campone M, et al. Ribociclib as first-line therapy for HR-positive, advanced breast cancer. N Engl J Med 2016; 375: 1738-48. (Among 668 postmenopausal women with advanced breast cancer treated with letrozole with or without ribociclib, progression-free survival was improved with ribociclib and adverse events were more frequent including neutropenia [59% vs 1%], infections [4.2% vs 2.4%] and ALT elevations [15.6% vs 3.9%], which were above 5 times ULN in 9.3% vs 1.2% and accompanied by bilirubin elevations in 1.2%). 27717303
Infante JR, Cassier PA, Gerecitano JF, Witteveen PO, Chugh R, Ribrag V, Chakraborty A, et al. A phase I study of the cyclin-dependent kinase 4/6 inhibitor ribociclib (LEE011) in patients with advanced solid tumors and lymphomas. Clin Cancer Res 2016; 23: 5696-705. (Among 132 patients with advanced solid tumors or lymphoma [Rb+] who were treated with different doses of ribociclib, dose limiting toxicities included neutropenia, thrombocytopenia, nausea, fatigue and prolongation of QTc interval; no mention of ALT elevations or hepatotoxicity). 27542767
Spring LM, Zangardi ML, Moy B, Bardia A. Clinical Management of potential toxicities and drug interactions related to cyclin-dependent kinase 4/6 inhibitors in breast cancer: practical considerations and recommendations. Oncologist 2017; 22 (9): 1039-48. (Review of the adverse side effects of palbociclib and ribociclib and their management, including recommendations for monitoring liver tests and product label recommendations on dose adjustments for liver test abnormalities). 28706010
Costa R, Costa RB, Talamantes SM, Helenowski I, Peterson J, Kaplan J, Carneiro BA, et al. Meta-analysis of selected toxicity endpoints of CDK4/6 inhibitors: palbociclib and ribociclib. Breast 2017; 35: 1-7. (Systematic review of adverse events from 7 publications on phase 2 and 3 trials of palbociclib and ribociclib discusses serious adverse events of symptoms [such as fatigue, nausea and rash], myelosuppression, neutropenic fever and thromboembolic events, but not ALT elevations or hepatotoxicity). 28618307
Syed YY. Ribociclib: First global approval. Drugs 2017; 77: 799-807. (Review of the mechanism of action, pharmacokinetics, clinical efficacy, current and planned clinical trials and toxicities of ribociclib shortly after its approval in the US [March 2017]). 28417244
O'Shaughnessy J, Petrakova K, Sonke GS, Conte P, Arteaga CL, Cameron DA, Hart LL, et al. Ribociclib plus letrozole versus letrozole alone in patients with de novo HR+, HER2- advanced breast cancer in the randomized MONALEESA-2 trial. Breast Cancer Res Treat 2018; 168: 127-34. (Secondary analysis of controlled trial ribociclib and letrozole vs letrozole alone in 668 postmenopausal women with advanced or metastatic breast cancer [Hortobagyi 2016], focusing on 227 with de novo cancer found improved progression-free survival with addition of ribociclib, but higher rates of adverse events, including any AST elevation in 17% vs 4% and values above 5 times ULN in 6% vs none). 29164421
Hortobagyi GN, Stemmer SM, Burris HA, Yap YS, Sonke GS, Paluch-Shimon S, Campone M, Pet al. Updated results from MONALEESA-2, a phase III trial of first-line ribociclib plus letrozole versus placebo plus letrozole in hormone receptor-positive, HER2-negative advanced breast cancer. Ann Oncol 2018 Apr 27. [Epub ahead of print] (Further follow up of results of trial of letrozole with or without ribociclib in 668 postmenopausal women with advanced or metastatic breast cancer [Hortobagyi 2016] reported no differences in overall survival with addition of ribociclib, but higher rates of adverse events including neutropenia [77% vs 6%] and abnormal liver tests [20% vs 6%]). 29718092
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/209092Orig1s000MultidisciplineR.pdf. (FDA review of the safety of ribociclib including descriptions of 4 cases of clinically apparent liver injury with jaundice; pages 145-7).

## OTHER REFERENCE LINKS

1. Recent References on Ribociclib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ribociclib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ribociclib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ribociclib)